# Naproxen

## OVERVIEW

### Introduction

Naproxen is a popular over-the-counter nonsteroidal antiinflammatory drug (NSAID) that is widely used for therapy of mild-to-moderate pain and arthritis. Naproxen has been associated with rare cases of clinically apparent drug induced liver injury.

### Background

Naproxen (na prox' en) belongs to the propionic acid class of NSAIDs similar to fenoprofen, ibuprofen, ketoprofen and oxaprozin. The antiinflammatory and analgesic properties of NSAIDs such as naproxen are mediated by inhibition of tissue cyclooxygenases (Cox-1 and -2), which results in a decrease in pro-inflammatory prostaglandins, important mediators in inflammatory and pain pathways. Naproxen has analgesic as well as antipyretic and antiinflammatory activity. It has a longer half-life than other commonly used NSAIDs, making a twice daily regimen feasible. Naproxen was approved for use by prescription in the United States in 1976 and for over-the-counter use in 1994. Currently more than 7 million prescriptions for naproxen are filled yearly and these numbers do not capture the wide scale over-the-counter sales. Naproxen is indicated for mild-to-moderate pain from various causes including trauma, tendonitis, headache, dysmenorrhea, and various forms of arthritis including osteoarthritis, rheumatoid arthritis, gout and ankylosing spondylitis. Generic and over-the-counter formulations are available as tablets, capsules and oral suspensions in multiple doses (125, 250, 225, 375, 500, 550 mg) under multiple commercial names including: Aleve, Anaprox, Naprosyn, Naxen, Naxodol, Neo-Prox, Nu-Naprox, Nycopren, Proxen, Synflex. Over-the-counter combinations with antihistamines are also available. The typical dose is 250 to 500 mg taken orally two or three times daily. As with other NSAIDs, naproxen is generally well tolerated, but side effects can include headache, dizziness, somnolence, dyspepsia, nausea, abdominal discomfort, heartburn, peripheral edema, infertility, fetal toxicity, and hypersensitivity reactions. Rare but potentially serious adverse events from NSAIDs such as naproxen include gastrointestinal ulceration, bleeding, and perforation, an increased risk for serious cardiovascular disease including myocardial infarction and stroke, renal dysfunction, exacerbation of asthma, infertility, and acute hypersensitivity reactions including anaphylaxis, exfoliative dermatitis, and Stevens Johnson syndrome.

### Hepatotoxicity

Serum aminotransferase levels can be elevated in as many as 4% of patients receiving prolonged courses of naproxen, particularly with high doses. Clinically apparent naproxen induced liver injury, however, is rare (approximately 1 in 10,000 new users), but convincing cases have been reported. The typical case resembles acute hepatitis and arises within 1 to 6 weeks of starting naproxen (Cases 1 and 2). The time to onset can be as long as 12 weeks, but convincing instances of liver injury arising after long term or intermittent low-dose use have not been described. The pattern of serum enzyme elevations can range from hepatocellular to cholestatic injury. Immunoallergic features and autoantibodies are not common, although rare cases of DRESS syndrome attributable to naproxen have been described including a syndrome of pulmonary infiltrates with eosinophilia (PIE). In most instances, recovery is rapid once naproxen is stopped. Rare instances of acute liver failure attributed to naproxen have been published, but the role of naproxen in these cases has not very convincingly shown. Reviews of hepatotoxicity often mention that naproxen is the least likely NSAID to cause serious liver injury.

Likelihood score: B (likely, but very rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of hepatotoxicity from naproxen is not known, but it is metabolized by the cytochrome P450 system and idiosyncratic injury may be due to a toxic or immunogenic metabolite. Cross sensitivity to hepatic injury with fenoprofen suggests that the propionic acid may be responsible for the injury. Alternatively, the liver injury attributed to naproxen may be caused by inhibition of cyclooxygenases by high-dose therapy which may cause cellular injury.

### Outcome and Management

Severity ranges from transient, asymptomatic elevations in serum aminotransferase levels, to hepatitis with jaundice, to fulminant liver failure leading to death or need for liver transplantation. In most cases, complete recovery is expected promptly after stopping the drug. Cross reactivity with other propionic acid derivatives, such as fenoprofen and ibuprofen, has been reported, and should thus be considered when switching the patient to an alternate NSAID or analgesic.

Drug Class: Nonsteroidal Antiinflammatory Drugs

## CASE REPORTS

### Case 1. Acute hepatitis due to naproxen.(1)

A 57 year old woman was started on naproxen (500 mg daily) for arthritis and ten days later developed nausea, abdominal pain and weakness, followed by jaundice. She had no previous history of liver disease, had no risk factors for viral hepatitis and did not drink alcohol. She was not taking other medications and had no history of adverse drug reactions. Blood tests showed bilirubin of 4.6 mg/dL with elevations in both ALT and alkaline phosphatase (Table). Tests for acute hepatitis A and B and for serum autoantibodies were negative. Abdominal ultrasound and ERCP showed no evidence of biliary obstruction. A liver biopsy showed acute hepatocellular necrosis. Naproxen was stopped, and she recovered rapidly. Approximately 2 months later, she was started on fenoprofen for recurrence of her arthritic pains. Within five days she developed nausea, abdominal pain and fatigue, and liver tests were abnormal. She recovered uneventfully after stopping fenoprofen.

#### Key Points

Medication: | Naproxen (500 mg daily for 14 days)
Pattern: | Hepatocellular (R=15)
Severity: | 3+ (hospitalized with jaundice)
Latency: | 7 days to symptoms, 10 to onset of jaundice
Recovery: | One to two months
Other medications: | None

#### Laboratory Values

Days After Starting | Days After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin (mg/dL) | Comments
0 | | Naproxen given for 14 days
10 | 0 | 450
19 | 0 | 500 | 280 | 4.6 | Admission: GGT 349
31 | 12 | 160 | 205
36 | 17 | 40 | 190 | | Discharged
72 | 43 | Fenoprofen started
6 | 0 | 300 | 320 | | Fenoprofen stopped
27 | 21 | 180 | 240
90 | 84 | 25 | 160
Normal Values | | <20 | <170 | <1.2

* Estimated from figure.

#### Comment

A striking and convincing example of an acute hepatitis caused by naproxen with a latency of only one week and rapid improvement with stopping the medication. Exposure to fenoprofen, a class-related NSAID, led to rapid recurrence with a similar pattern of serum enzyme elevations. The propionic acid derivative class of NSAIDs include ibuprofen, naproxen, fenoprofen and oxaprozin.

### Case 2. Acute hepatocellular injury and jaundice after a single dose of naproxen.(2)

A 57 year old woman took a single dose of naproxen for abdominal pain and six days later developed generalized itching and jaundice. On admission to the hospital 4 days later, she was jaundiced but had no fever, rash or eosinophilia. Blood tests showed bilirubin of 22 mg/dL with marked elevations in ALT and minimal increases in alkaline phosphatase levels (Table). She tested positive for antibody to hepatitis A, but an IgM assay was evidently not done. Tests for hepatitis B and C (including HCV RNA), CMV and EBV were negative as were relevant autoantibodies. Ultrasound and CT scans of the abdomen were unremarkable. Liver biopsy showed intrahepatic cholestasis and variable degrees of hepatocellular necrosis. She recovered slowly, but completely over the next five months.

#### Key Points

Medication: | Naproxen (one tablet, unknown amount)
Pattern: | Hepatocellular (R=30)
Severity: | 3+ (hospitalized with jaundice)
Latency: | 6 days to symptoms and jaundice
Recovery: | Five months
Other medications: | None mentioned

#### Laboratory Values

Weeks After Starting | Weeks After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
0 | | One dose of naproxen taken
1 | 1 | 2023 | 80 | 22 | Admission
2 | 2 | 1549 | 58 | 32 | Liver biopsy
3 | 3 | 622 | 65 | 37
11 | 11 | 183 | 72 | 1.4
15 | 15 | 97 | 47 | 0.6
21 | 21 | 17 | 17 | 0.7
Normal Values | | <70 | <100 | <1.2

#### Comment

A remarkable case of acute hepatocellular jaundice arising within a week of taking a single tablet of naproxen. The case report provides little information about past medical history of possible exposures to viral hepatitis or other toxins, and serological tests were incomplete to rule out acute hepatitis A. Typical of naproxen induced liver injury was the short incubation period and the ultimate resolution of the hepatitis with no further exposure. However, the naproxen may have been co-incidental or actually taken to treat initial symptoms of an unrelated acute hepatic injury. Nevertheless, naproxen has been clearly implicated in a number of cases of acute hepatocellular injury and rechallenge would be foolhardy. The patient should be advised to avoid most other NSAIDs of the propionic class.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Naproxen – Generic, Aleve®, Anaprox®, Naprosyn®

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=NAPROXEN&pagesize=20&page=1)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Naproxen | 22204-53-1 | C14-H14-O3

## CITED REFERENCES

1 Andrejak M, Davion T, Gineston JL, Capron JP. Cross hepatotoxicity between non-steroidal anti-inflammatory drugs. Br Med J (Clin Res Ed) 1987; 295: 180-1.3115366
2 Demirag MD, Ozenirler S, Goker B, Poyraz A, Haznedaroglu S, Ozturk MA. Idiosyncratic toxic hepatitis secondary to single dose of naproxen. Acta Gastroenterol Belg 2007; 70: 247-8.17715646

## ANNOTATED BIBLIOGRAPHY

References updated: 20 July 2025

Abbreviations used: NSAID, nonsteroidal anti-inflammatory drug; COX-1 and -2, cyclo-oxygenase 1 and 2; PIE, pulmonary infiltrates with eosinophilia; DRESS, drug reaction with eosinophilia and systemic symptoms; VBDS, vanishing bile duct syndrome.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. The NSAIDS. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-41. (Review of hepatotoxicity of NSAIDs published in 1999 mentions that the variable onset of injury and scanty data on specific cases make it difficult to assign causality or a specific mechanism of hepatic injury from naproxen).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. pp. 370-402. (Expert review of hepatotoxicity of NSAIDs mentions that only a few cases of hepatic injury due to naproxen have been reported and the clinical features and possible pathogenesis are not well defined).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. pp. 685-709. (Textbook of pharmacology and therapeutics).
Frenger W, Morbach HJ. [Clinical trial with naproxen, with particular consideration to tolerance]. Scand J Rheumatol Suppl 1973; 2: 137-9. German. (Experience in 50 patients with arthritis given naproxen for 28 days; 3 patients had minimal ALT elevations, 16-20 mU). 4590038
Bass BH. Letter: Jaundice associated with naproxen. Lancet 1974; 1: 998. (35 year old woman developed jaundice [bilirubin 3.1 mg/dL, Alk P ~10x elevated, AST normal] 2-3 months after starting naproxen which resolved upon stopping). 4133693
Law IP, Knight H. Jaundice associated with naproxen. N Engl J Med 1976; 295: 1201. (54 year old woman developed jaundice [bilirubin 2.5 mg/dL; AST 1000 U/L, Alk P 400 U/L] 1 week after starting naproxen, resolving within 4 weeks). 980029
Krogsgaard K, Hardt F, Malchow-Møller A. [Liver involvement after treatment with naproxen] Ugeskr Laeger 1980; 142: 450-1. Danish. (57 year old man developed nausea after two doses of naproxen with jaundice arising a few days later [bilirubin 8.2 mg/dL, ALT 70 U/L, Alk P 760 U/L], resolving within 4 to 5 weeks). 7368395
Victorino RM, Silveira JC, Baptista A, de Moura MC. Jaundice associated with naproxen. Postgrad Med J 1980; 56: 368-70. (66 year old man developed jaundice [bilirubin 5.8 mg/dL, AST 102 U/L, Alk P 4 times ULN] 1 month after starting naproxen, resolving within few weeks of stopping). 7443602
Giarelli L, Falconieri G, Delendi M. Fulminant hepatitis following naproxen administration. Hum Pathol 1986; 17: 1079. Erratum in: Hum Pathol 1987; 18: 205. (25 year old woman developed acute liver failure 1 month after a 5 day course of naproxen by suppository [bilirubin 18 mg/dL, ALT 1100 U/L, Alk P 196 U/L], other causes not completely ruled out). 3759067
Grattan CEH. Pustular reaction to naproxen with cholestatic jaundice. Dermatologica 1989; 179: 57-8. (Brief description of a patient who developed pustular dermatosis and cholestatic jaundice while taking naproxen for osteoarthritis; no details given of time of onset or liver test results). 2527771
Reeve PA, Moshiri M, Bell GD. Pulmonary oedema, jaundice and renal impairment with naproxen. Br J Rheumatol 1987; 26: 70-1. (53 year old man developed pulmonary edema 1 week after starting naproxen followed by fever and jaundice [bilirubin 5.5 mg/dL, Alk P 72 U/L, AST 36 U/L], with little inflammation on liver biopsy and rapid recovery). 3814977
Andrejak M, Davion T, Gineston JL, Capron JP. Cross hepatotoxicity between non-steroidal anti-inflammatory drugs. Br Med J (Clin Res Ed) 1987; 295: 180-1. (67 year old woman developed jaundice [bilirubin 4.9 mg/dL, ALT 250 U/L, Alk P 280 U/L] 9 days after starting naproxen, with rapid resolution, but recurrence in 4 days upon exposure to fenoprofen: Case 1). 3115366
Smolinske SC, Hall AH, Vandenberg SA, Spoerke DG, McBride PV. Toxic effects of nonsteroidal anti-inflammatory drugs in overdose. An overview of recent evidence on clinical effects and dose-response relationships. Drug Saf 1990; 5: 252-74. (Review of literature on overdose of NSAIDs; overdose of naproxen typically causes gastrointestinal upset, metabolic acidosis and drowsiness, stupor and coma; one instance of very transient jaundice with ALT 64 U/L has been described). 2198051
Bell H, Raknerud N. [Fulminating hepatitis after treatment with naproxen and/or disulfiram?] Tidsskr Nor Laegeforen 1991; 111: 322-3. Norwegian. (Abstract only: 49 year old woman developed acute liver failure 6 weeks after starting disulfiram and 5 days after starting naproxen [bilirubin 26.4 mg/dL, ALT 2815 U/L], probably too rapid an onset for naproxen and more likely due to disulfiram). 2000613
Zimmerman HJ. Update of hepatotoxicity due to classes of drugs in common clinical use: non-steroid drugs, anti-inflammatory drugs, antibiotics, antihypertensives, and cardiac and psychotropic agents. Semin Liver Dis 1990; 10: 322-8. (Review article; naproxen listed as rare cause of hepatic injury with only 5 published cases, usually cholestatic, probably due to idiosyncrasy). 2281340
Jick H, Derby LE, García Rodríguez LA, Jick SS, Dean AD. Liver disease associated with diclofenac, naproxen, and piroxicam. Pharmacotherapy 1992; 12: 207-12. (Analysis of UK database on 102,644 persons receiving NSAIDs, including 50,6676 on naproxen; 14 cases of suspected drug induced liver disease; most due to diclofenac, cases in patients on naproxen usually had another possible cause). 1608854
Goodwin SD, Glenny RW. Nonsteroidal anti-inflammatory drug-associated pulmonary infiltrates with eosinophilia. Review of the literature and Food and Drug Administration Adverse Drug Reaction reports. Arch Intern Med. 1992;152:1521-4.. (68 year old man with osteoarthritis treated with naproxen developed cough and dyspnea on exertion accompanied by eosinophilia [1470/μL] and upper lobe pulmonary infiltrates that resolved within weeks of stopping; he later admitted to 3 previous similar episodes following a few weeks of naproxen therapy; review of literature and FDA database revealed at least 20 further naproxen related cases of pulmonary infiltrates with eosinophilia [PIE]). 1627033
Carson JL, Strom BL, Duff A, Gupta A, Das K. Safety of nonsteroidal anti-inflammatory drugs with respect to acute liver disease. Arch Intern Med 1993; 153: 1331-6. (Analysis of Medicaid database from Michigan and Florida from 1980-87 found 107 cases of acute idiopathic hepatitis [2.2/100,000], of whom 8.4% received NSAIDs and 0.9% naproxen, compared to 6.1% and 1.6% of 428 case-controls, suggesting little contribution of NSAIDs to acute liver injury). 8507123
García Rodríguez LA, Williams R, Derby LE, Dean AD, Jick H. Acute liver injury associated with nonsteroidal anti-inflammatory drugs and the role of risk factors. Arch Intern Med 1994; 154: 311-6. (Retrospective cohort study of cases of acute liver injury in England after exposure to NSAIDs; 23 cases, but none fatal, including 5 from ibuprofen, 4 diclofenac, 4 naproxen, 2 mefenamic acid, 3 ketoprofen, 2 piroxicam, 2 fenbufen and 3 sulindac). 8297198
D'Amore F, Agostino A, Santoro A. Drug-induced cholestasis. Clinical contribution. Minerva Gastroenterol Dietol 1996; 42: 215-9. (61 year old developed jaundice 15 days after starting an 8-day course of naproxen [bilirubin 11.7 mg/dL, ALT 117 U/L, Alk P 277 U/L], resolving within 2 months). 17912213
Manoukian AV, Carson JL. Nonsteroidal anti-inflammatory drug-induced hepatic disorders. Incidence and prevention. Drug Saf 1996; 15: 64-71. (Review article focusing largely on diclofenac and sulindac; naproxen is associated with abnormal liver enzymes in ~4%; acute liver injury in 3.8/100,000 users). 8862964
Walker AM. Quantitative studies of the risk of serious hepatic injury in persons using nonsteroidal antiinflammatory drugs. Arthritis Rheum 1997; 40: 201-8. (Review of population based studies of NSAID use and hepatic injury; frequency of clinically apparent liver injury from NSAIDs was ~10 cases per 100,000 patient-years of use, ranging from 9 to 12 per 100,000 for naproxen). 9041931
Pérez-Gutthann S, García-Rodríguez LA, Duque-Oliart A, Varas-Lorenzo C. Low-dose diclofenac, naproxen, and ibuprofen cohort study. Pharmacotherapy 1999; 19: 854-9. (Analysis of database of general practice in UK on 3 million persons; analysis of 1991-5 of patients receiving first prescription for diclofenac [n=22,146], naproxen [n=46,919] or ibuprofen [n=54,830] in low doses similar to what might be given over-the-counter, found 64 complications, 13 liver injury, but only 3 confirmed, 1 naproxen [0.2/10,000], 2 ibuprofen [0.4/10,000], none diclofenac). 10417034
Bareille MP, Montastruc JL, Lapeyre-Mestre M. [Liver damage and nonsteroidal anti-inflammatory drugs: case non-case study in the French Pharmacovigilance Database] Therapie 2001; 56: 51-5. French. (Using French database, overall 13% of adverse events due to NSAIDs were hepatic injury, including 15.7% of naproxen reports, but concomitant exposures to other hepatotoxins were frequent). 11322018
Traversa G, Bianchi C, Da Cas R, Abraha I, Menniti-Ippolito F, Venegoni M. Cohort study of hepatotoxicity associated with nimesulide and other non-steroidal anti-inflammatory drugs. BMJ 2003; 327: 18-22. (Among 397,537 patients who received a prescription for an NSAID [770,000 person years] between 1997 and 2002, 42 developed an acute non-viral hepatitis requiring hospitalization including 2 of 7833 receiving naproxen). 12842950
Teoh NC, Farrell GC. Hepatotoxicity associated with non-steroidal anti-inflammatory drugs. Clin Liver Dis 2003; 7: 2: 401-13. (Review article on NSAIDs, naproxen said to cause cholestatic or mixed injury and to be low in incidence). 12879991
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Review of UNOS database from 1990-2002, found 270 cases of acute liver failure undergoing liver transplant due to medications; one case reportedly due to naproxen). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of drug induced liver injury with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; among 103 cases, 3 attributed to naproxen without specific details given). 16165719
Andrade RJ, Lucena MI, Fernandez MC, Pelaez G, Pachkoria K, Garcia-Ruiz E, et al. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports of Spanish drug induced liver injury network on 570 cases, ibuprofen and diclofenac, but not naproxen mentioned among the 20 most frequent causes with >4 cases). 16083708
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports; [89% from the US]; 21 drugs were associated with >50 cases, including diclofenac [15th], but not naproxen). 16054882
Demirag MD, Ozenirler S, Goker B, Poyraz A, Haznedaroglu S, Ozturk MA. Idiosyncratic toxic hepatitis secondary to single dose of naproxen. Acta Gastroenterol Belg 2007; 70: 247-8. (57 year old woman developed jaundice 6 days after taking a single dose of naproxen [bilirubin 22 mg/dL, ALT 2196 U/L, Alk P 80 U/L], with resolution over the next 5 months; other causes sought, but not identified: Case 2). 17715646
Ting TV, Hashkes PJ. Methotrexate/naproxen-associated severe hepatitis in a child with juvenile idiopathic arthritis. Clin Exp Rheumatol 2007; 25: 928-9. (Onset of severe liver injury in 2 year old child with juvenile rheumatoid arthritis, after 10 months exposure to methotrexate and naproxen, with recovery after stopping therapy; hypothesized that naproxen had a synergistic effect with methotrexate). 18173932
Aithal GP, Day CP. Nonsteroidal anti-inflammatory drug-induced hepatotoxicity. Clin Liver Dis 2007; 11: 563-75, vi-vii. (Review of hepatotoxicity of NSAIDs; naproxen not specifically discussed). 17723920
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam and 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen]). 18955056
Soni P, Shell B, Cawkwell G, Li C, Ma H. The hepatic safety and tolerability of the cyclooxygenase-2 selective NSAID celecoxib: pooled analysis of 41 randomized controlled trials. Curr Med Res Opin 2009; 25: 1841-51. (A retrospective analysis of a pharmaceutical company's dataset on 41 studies of patients with various inflammatory conditions treated with NSAIDs; adverse events for celecoxib, diclofenac, naproxen, ibuprofen vs placebo were analyzed; incidence of hepatic adverse events due to celecoxib was similar for placebo and ibuprofen or naproxen, but lower than for diclofenac). 19530981
Carrascosa MF, Lucena MI, Andrade RJ, Caviedes JR, Lavín AC, Mones JC, Rivero AP, et al. Fatal acute hepatitis after sequential treatment with levofloxacin, doxycycline, and naproxen in a patient presenting with acute Mycoplasma pneumoniae infection. Clin Ther 2009; 31: 1014-9. (63 year old man with pneumonia developed jaundice 10 days after starting antibiotics and naproxen progressing to hepatic failure and death within 27 days [initial bilirubin 4.0 ALT 1577, Alk P 189 U/L]; causality assessment implicated levofloxacin, doxycycline, and naproxen). 19539102
Bessone F. Non-steroidal anti-inflammatory drugs: What is the actual risk of liver damage? World J Gastroenterol 2010; 16: 5651-61. (Review of estimated frequency of drug induced liver injury due to NSAIDs from large published epidemiological studies; mentions that naproxen has been associated with various hepatic reactions). 21128314
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children; naproxen is not listed among the top 41 causes). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 7 were due to NSAIDs, including 4 attributed to bromfenac, 2 to diclofenac and 1 to etodolac, but none to naproxen). 20949552
Ali S, Pimentel JD, Ma C. Naproxen-induced liver injury. Hepatobiliary Pancreat Dis Int. 2011; 10: 552-6. (30 year old woman with lupus erythematosus on long term prednisone developed jaundice a few weeks after starting naproxen [bilirubin 10.5 mg/dL, ALT 926 U/L, Alk P 472 U/L], with persistence of Alk P elevations and reduced numbers of bile ducts on liver biopsy that gradually improved; liver tests becoming normal 10 years later and liver biopsy showing partial return of bile ducts). 21947732
Hunter LJ, Wood DM, Dargan PI. The patterns of toxicity and management of acute nonsteroidal anti-inflammatory drug (NSAID) overdose. Open Access Emerg Med. 2011 Jul 6;3:39-48.. (Review of the clinical features of severe outcomes of overdose with NSAIDs mentions that acetaminophen is the most frequent cause of overdose with analgesics followed by ibuprofen and then naproxen, but significant liver injury as a result of naproxen overdose is rare). 27147851
Vogts N, Young S. Pulmonary infiltrates with eosinophilia syndrome in ibuprofen overdose. N Z Med J. 2012;125:74-5.. (45 year old woman developed 2 days of drowsiness after an overdose of “Neurofen Plus” tablets [codeine and ibuprofen] with metabolic acidosis, renal dysfunction, and bilateral patchy pulmonary infiltrates with eosinophilia [600/uL] which improved within 5 days and chest X-ray was normal after 4 weeks, an example of PIE syndrome which has been reported with multiple NSAIDs including diclofenac, naproxen, meloxicam, fenbufen, nimesulide and diflunisal). 22932657
Lapeyre-Mestre M, Grolleau S, Montastruc JL; Adsociation Française des Centres Régionaux de Pharmacovigilance (CRPV). Adverse drug reactions associated with the use of NSAIDs: a case/noncase analysis of spontaneous reports from the French pharmacovigilance database 2002-2006. Fundam Clin Pharmacol 2013; 27: 223-30. (Analysis of 42,389 spontaneous serious adverse event reports to the French Pharmacovigilance database on 8 NSAIDs between 2002 and 2006; liver adverse events were most frequent with nimesulide [0.15 per million daily doses] compared to diclofenac [0.09], ketoprofen [0.09] piroxicam [0.06], naproxen [0.04], meloxicam [0.03], and tenoxicam [0.03]). 21929527
Gulmez SE, Larrey D, Pageaux GP, Lignot S, Lassalle R, Jové J, Gatta A, et al. Transplantation for acute liver failure in patients exposed to NSAIDs or paracetamol (acetaminophen): the multinational case-population SALT study. Drug Saf 2013; 36: 135-44. (Among 600 patients undergoing liver transplantation for acute liver failure at 52 European liver transplant centers between 2005 and 2007, 301 were considered idiopathic and had received a medication within 30 days of onset; including acetaminophen in 192 and NSAIDs in 44, including diclofenac [the most commonly used NSAID] in 7, but naproxen in only 2 for a rate of 1.6 per million treatment years). 23325533
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 6 attributed to diclofenac [ranking 2nd], but none for naproxen or other NSAIDs). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common class of implicated agents being NSAIDs [n=62, 32%], and specific agents were nimesulide [n=53], piroxicam [5], diclofenac [2], gold salts [1], and naproxen [1]). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 were attributed to NSAIDs [Schmeltzer 2016]). 25754159
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9. (Among 1221 cases of drug induced liver injury enrolled in a prospective, US database between 2004 and 2014, 30 cases [2.5%] were attributed to NSAIDs, most commonly diclofenac [n=16], but also celecoxib [3], meloxicam [3], etodolac [2], ibuprofen [2], oxaprozin [2], valdecoxib [1] and sulindac [1], but not naproxen). 26601797
Donati M, Conforti A, Lenti MC, Capuano A, Bortolami O, Motola D, Moretti U, et al.; DILI-IT Study Group. Risk of acute and serious liver injury associated to nimesulide and other NSAIDs: data from drug-induced liver injury case-control study in Italy. Br J Clin Pharmacol 2016; 82: 238-48. (Among 179 cases of acute liver injury and 1770 controls admitted to 9 Italian hospitals between 2010 and 2014, NSAIDs used more frequently in cases compared to controls included nimesulide [17% vs 10%: odds ratio 1.88] and ibuprofen [14% vs 10%: odds ratio 1.59] and risk was higher in those taking higher doses). 26991794
Zoubek ME, González-Jimenez A, Medina-Cáliz I, Robles-Díaz M, Hernandez N, Romero-Gómez M, Bessone F, et al. High Prevalence of ibuprofen drug-induced Liver injury in Spanish and Latin-American registries. Clin Gastroenterol Hepatol 2018; 16: 292-4. (Analysis of a Spanish and Latin-American registries identified 73 cases of NSAID induced liver injury, the most common agents being nimesulide [38%], diclofenac [34%] and ibuprofen [17%]; naproxen and other NSAIDs not mentioned). 28782674
Tujios SR, Lee WM. Acute liver failure induced by idiosyncratic reaction to drugs: challenges in diagnosis and therapy. Liver Int 2018; 38: 6-14. (Review of acute liver failure and the contribution of drug induced liver injury, of which 5% were due to NSAIDs, most commonly diclofenac and etodolac). 28771932
Meunier L, Larrey D. Recent advances in hepatotoxicity of non-steroidal anti-inflammatory drugs. Ann Hepatol 2018; 17: 187-91. (Review of the hepatotoxicity of NSAIDS mentions the most commonly implicated are diclofenac, nimesulide, sulindac, ibuprofen, piroxicam, naproxen and aspirin). 29469052
Teschke R. Top-ranking drugs out of 3312 drug-induced liver injury cases evaluated by the Roussel Uclaf Causality Assessment Method. Expert Opin Drug Metab Toxicol. 2018;14:1169-1187.. (In a review of 3312 published cases of drug-induced liver injury using RUCAM to define causality, diclofenac ranked 5^th^ and ibuprofen ranked 8^th^ in frequency, whereas naproxen is not mentioned). 30354694
Gulmez SE, Unal US, Lassalle R, Chartier A, Grolleau A, Moore N. Risk of hospital admission for liver injury in users of NSAIDs and nonoverdose paracetamol: Preliminary results from the EPIHAM study. Pharmacoepidemiol Drug Saf. 2018;27:1174-1181.. (In a case-population controlled study of a French hospitalization claims database, 63 cases of acute liver injury were identified, 13 of which had been exposed recently to an NSAID including 6 to diclofenac, 4 to ibuprofen, 3 to ketoprofen, but none to naproxen). 30112779
Guerrero Gómez DA, París Zorro S, Aponte Barrios W, Carrillo Bayona JA. Drug reaction with eosinophilia and systemic symptoms (DRESS) with severe and atypical lung involvement. Radiol Case Rep. 2020;15:2178-2182.. (22 year old woman developed rash and dyspnea 5 days after starting naproxen for back pain, evaluation showing multilobular pulmonary consolidation and pleural effusions with eosinophilia and “hypertransaminasemia suggestive of acute liver failure” but no details of liver function provided and resolution with corticosteroid therapy). 32944113
Nonopioid drugs for pain. Med Lett Drugs Ther. 2022;64(1645):33-40.. (Concise review of the nonopioid drugs for pain mentions that NSAIDs are considered to be more effective than acetaminophen for mild to moderate pain and that they can cause small increases in serum aminotransferase levels but that serious hepatotoxicity is rare, occurring most frequently with diclofenac, while cholestatic hepatitis has been reported with use of celecoxib). 35231019
Sharma S, Sharma A, Surya M, Guleria S, Bansal N. Clinician's dilemma: naproxen-induced liver injury. Indian J Pathol Microbiol. 2023;66:168-170.. (13 year old Indian girl with juvenile rheumatoid arthritis developed jaundice without rash or fever 1 month after starting naproxen [250 mg twice daily] with tapering doses of prednisone [bilirubin 7.1 rising to 11.9 mg/dL, ALT 2125 U/L, Alk P 260 U/L, ANA negative] resolving within a month of stopping therapy, at which time all liver tests were normal). 36656233
Ma J, Björnsson ES, Chalasani N. The safe use of analgesics in patients with cirrhosis: a narrative review. Am J Med. 2024;137:99-106.. (Review of the safety of analgesic use in patients with cirrhosis, mentions that acetaminophen is considered the safest nonopioid but that the dose should be limited to 2 g daily with prolonged therapy in persons with cirrhosis and that NSAIDs are generally thought to be contraindicated in patients with cirrhosis, but celecoxib can be used at typical doses with Child’s class A cirrhosis (compensated), but should be reduced by 50% in patients with Child’s B and avoided in those with Child’s C cirrhosis). 37918778
Kim B, Cho JY, Song I, Oh J. Pharmacogenetic analysis of an 8-year old girl with Reye syndrome associated with use of naproxen. Am J Case Rep. 2024;25:e942242.. (8 year old Korean girl with 3 days of fever was started on naproxen and 3 days later had hypotension, loss of consciousness and seizures [bilirubin 0.8 mg/dL, ALT 132 U/L, AST 955 U/L, Alk P 132 U/L, LDH 8040 U/L, ammonia 93 mcg/dL, creatinine 2.0 mg/dL] with rapid improvement after stopping but subsequent documentation of similar episode in the past). 38311849
Bonkovsky HL, Ghabril M, Nicoletti P, Dellinger A, Fontana RJ, Barnhart H, Gu J, et al; US DILIN Investigators. Drug-induced liver injury (DILI) ascribed to non-steroidal anti-inflammatory drugs (NSAIDs) in the USA-Update with genetic correlations. Liver Int. 2024;44:1409-1421.. (Among 55 cases of drug induced liver injury attributed to NSAIDs enrolled in a U.S. database between 2004 and 2022, 29 were attributed to diclofenac, 7 to celecoxib, 5 to ibuprofen, 4 to etodolac and meloxicam, 2 to oxaprozin, but only 1 to naproxen and sulindac). 38451034
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be attributed to prescribed medications, at rates for NSAIDs of 1:7,700 for sulindac, 1:8,300 for indomethacin, 1:9,100 for naproxen, 1:11,000 for ibuprofen, 1:12,500 for diclofenac, and 1:14,300 for celecoxib). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, 49 were attributed to NSAIDs, including 19 [4.1%] due to diclofenac, 14 [3.0%] to nimeslide, and 11 [2.4%] to ibuprofen; the implicated agents of the remaining 5 NSAID cases were not mentioned). 38992407
Selvam S, Bansal A, Singh H, Dhibhar DP, Suri V, Bhalla A. Naproxen-induced liver injury in a case of adult-onset Still's disease. Trop Doct. 2025;55:62-64.. (31 year old woman with newly diagnosed adult-onset Still’s disease and history of allergy to ibuprofen developed anorexia and weakness 10 days after starting naproxen [bilirubin 6.1 mg/dL, ALT 675 U/L, Alk P 321 U/L] with almost complete resolution within a month of stopping). 39344440

## OTHER REFERENCE LINKS

1. Recent References on Naproxen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(naproxen/AE+NOT+clavulanic+acid)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Naproxen: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=naproxen)